# Pimozide

## OVERVIEW

### Introduction

Pimozide is a conventional antipsychotic used largely in the therapy of Tourette syndrome. Pimozide therapy has not been associated with serum aminotransferase elevations nor with cases of clinically apparent acute liver injury.

### Background

Pimozide (pim' oh zide) is a diphenylbutylpiperidine derivative that differs structurally from the phenothiazines and appears to act by blocking dopamine type 2 (D2) receptors. Pimozide has other central and peripheral effects including anticholinergeric and alpha adrenergic blockade. Pimozide is indicated for the therapy of severe motor and verbal tics in patients with Tourette syndrome. It has also been used in therapy of schizophrenia. Pimozide was approved for use in the United States in 1984. As therapy of schizophrenia, pimozide has been replaced in large part by the atypical antipsychotics, which have fewer extrapyramidal side effects. Pimozide continues to be used in patients with motor or verbal tics due to Tourette syndrome. Pimozide is available as tablets of 1 and 2 mg in generic forms and under the brand name Orap. Typical doses are 1 to 2 mg daily in divided doses, increasing to a maximum of 10 mg daily. Pimozide can prolong the QT interval and, in rare instances, has caused sudden death for which reason the dose should be carefully chosen and drug levels monitored. Common side effects include drowsiness, dizziness, headache, blurred vision, dry mouth, and constipation. Uncommon but potentially severe adverse reactions include tardive dyskinesia, neuroleptic malignant syndrome and sudden death.

### Hepatotoxicity

Liver test abnormalities have not been reported to occur in of patients on pimozide, but the degree and duration of monitoring done in initial studies were not clear. Instances of clinically apparent acute liver injury have not been reported due to pimozide, and thus must be rare if they occur at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Pimozide is extensively metabolized by the liver partially via the cytochrome P450 system (predominantly CYP 2D6) and levels can be seriously elevated in patients who concurrently receive CYP 2D6 inhibitors, particularly in persons who are poor metabolizers of CYP 2D6 substrates. The lack of hepatotoxicity may relate in part to the low dosage used (less than 10 mg daily).

Drug Class: Antipsychotic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pimozide – Generic, Orap®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pimozide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Pimozide | 2062-78-4 | C28-H29-F2-N3-O

## ANNOTATED BIBLIOGRAPHY

References updated: 01 July 2020

Zimmerman HJ. Neuroleptic drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-91. (Expert review of hepatotoxicity of neuroleptic drugs published in 1999; mentions a single case of cholestatic jaundice due to pimozide). Larry D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of psychiatric agents does not discuss pimozide).
Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
Claghorn JL. (1974). A double-blind comparison of pimozide vs. trifluoperazine in schizophrenic outpatients. Curr Ther Res Clin Exp. (Small trial of 6 months of pimozide vs trifluoperazine therapy in 87 subjects with monitoring of serum tests; 3 on pimozide and 6 on trifluoperazine had “some transient laboratory alterations”, but which tests, by how much and when was not defined).
Kolivakis T, Azim H, Kingstone E. (1974). A double-blind comparison of pimozide and chlorpromazine in the maintenance care of chronic schizophrenic outpatients. Curr Ther Res Clin Exp. (Trial of pimozide vs chlorpromazine for 6 months with laboratory monitoring, no mention of ALT elevations or hepatotoxicity).
Pinder RM, Brogden RN, Swayer R, Speight TM, Spencer R, Avery GS. (1976). Pimozide: a review of its pharmacological properties and therapeutic uses in psychiatry. Drugs. (Short review of pharmacology, indications and side effects of pimozide; no mention of ALT elevations or hepatotoxicity).
Colvin CL, Tankanow RM. (1985). Pimozide: use in Tourette's syndrome. Drug Intell Clin Pharm. (Review of structure, pharmacology and efficacy of pimozide in short term studies in Tourette syndrome; no mention of hepatotoxicity).
Allison DB, Mentore JL, Heo M, Chandler LP, Cappelleri JC, Infante MC, Weiden PJ. (1999). Antipsychotic-induced weight gain: a comprehensive research synthesis. Am J Psychiatry. (Systematic review of 81 articles on weight change with antipsychotics, using change after 10 weeks to compare agents: clozapine +5.7, olanzapine +4.2, chlorpromazine +4.2, risperidone +1.7, loxapine +0.6, haloperidol +0.5, ziprasidone +0.3, molindone -0.1, and pimozide -2.7 kg).
Rogers HL, Bhattaram A, Zineh I, Gobburu J, Mathis M, Laughren TP, Pacanowski M. (2012). CYP2D6 genotype information to guide pimozide treatment in adult and pediatric patients: basis for the U.S. Food and Drug Administration's new dosing recommendations. J Clin Psychiatry. (Review of the pharmacogenetics of pimozide and the role of CYP 2D6 and CYP 2D6 inhibitors in its metabolism and adverse events).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, only one of which was attributed to chlorpromazine, the only antipsychotic medication listed).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 cases [0.6%] were attributed to antipsychotic agents, including 3 due to quetiapine and 2 to olanzapine, but none to pimozide]).

## OTHER REFERENCE LINKS

1 Recent References on Pimozide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Pimozide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pimozide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pimozide)